# Enfuvirtide

## OVERVIEW

### Introduction

Enfuvirtide is an HIV fusion inhibitor, the first of this class of agents active against the human immunodeficiency virus (HIV). Enfuvirtide has not been associated with serum aminotransferase elevations during therapy or episodes of acute, clinically apparent liver injury.

### Background

Enfuvirtide (en fue' vir tide) is relatively new antiretroviral drug that blocks the fusion of HIV to target cell, preventing viral entry and subsequent infection. Enfuvirtide is a 36 amino acid biomimetic peptide that resembles the HIV proteins that are responsible for the fusion of the virus to cell membranes and subsequent intracellular uptake. Enfuvirtide has both in vitro and in vivo activity against HIV, and several randomized controlled trials have shown that it leads to significant decline in HIV RNA levels and rises in peripheral CD4 T cell counts. Enfuvirtide was approved for use in the United States in 2003, but it has had limited use, partially because it requires parenteral administration once or twice daily. Enfuvirtide is available in single use vials that contain 90 mg/mL after reconstitution under the brand name of Fuzeon. The recommended regimen for enfuvirtide is 90 mg subcutaneously twice daily in adults and 2 mg/kg in children ages 6 to 16. Enfuvirtide is recommended only in combination with other antiretroviral agents. The only common side effects specifically linked to enfuvirtide have been injection site reactions (which can be troublesome) and eosinophilia. Regimens that include enfuvirtide have the potential to cause immune reconstitution syndrome, pneumonitis and severe hypersensivity reactions.

### Hepatotoxicity

Enfuvirtide has not been reported to cause serum aminotransferase elevations at rates higher than in controls receiving similar antiretroviral therapy. No instances of clinically apparent liver injury due to enfuvirtide have appeared in the published literature. Enfuvirtide has, however, not been a widely used agent. Partially because it requires twice daily parenteral injections. Enfuvirtide is associated with rare (<1%) instances of hypersensitivity reactions with eosinophilia, rash and systemic symptoms which can be accompanied by transient serum aminotransferase elevations, but other symptoms of hypersensitivity dominate the clinical picture.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Enfuvirtide is a polypeptide and is catabolized to its constituent amino acids and rapidly cleared from the circulation. Hepatic metabolism is minimal and enfuvirtide does not affect the CYP 450 system.

### Outcome and Management

If enfuvirtide hepatotoxicity occurs independent of minor aminotransferase elevations accompanying hypersensitivity reactions, it must be rare. Nevertheless, the product label for enfuvirtide mentions the possibility of toxic hepatitis and steatosis.

Drug Class: Antiviral Agents

## CASE REPORT

### Case 1. Serum enzyme elevations during enfuvirtide/tipranavir/ritonavir therapy.

[Modified from: Jülg B, Bogner JR, Goebel FD. Severe hepatotoxicity associated with the combination of enfuvirtide and tipranavir/ritonavir: case report. AIDS 2006; 20:1563. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16847416)]

A 52 year old man with long standing HIV-HBV coinfection and exposure to multiple antiretroviral agents, developed serum aminotransferase elevations 2 weeks after having tipranavir/ritonavir added to a chronic regimen of zidovudine, lamivudine and enfurvitide. Serum enzymes, which had been normal before therapy, included ALT 538 U/L and GGT 238 U/L. A liver biopsy was done that showed mild hepatitis and no steatosis. At the patient’s request, enfuvirtide rather than tipranavir was stopped, and serum enzymes decreased by 50%. Serum GGT levels increased and at this point, tipranavir was stopped, whereupon all liver tests returned to normal during the next 4 weeks. Serial levels of HBV DNA were not available, but at the height of the enzyme elevations, HBV DNA was 20,000 copies/mL.

#### Key Points

Medication: | Tipranavir/ritonavir
Pattern: | Hepatocellular (R=5.5, based upon GGT results)
Severity: | Mild (ALT elevations without jaundice)
Latency: | 2 weeks
Recovery: | 4 weeks
Other medications: | Ritonavir, zidovudine, lamivudine, enfurvitide

#### Comment

A complex course in a patient with multidrug resistant HIV infection on five antiretroviral agents. Serum ALT levels rose after addition of tipranavir to his chronic regimen. Stopping enfuvirtide was followed by partial improvement in liver tests, but complete resolution came only with stopping tipranavir. Tipranavir with low dose ritonavir has been associated with prominent ALT elevations (at least 5 times the upper limit of the normal range) in up to 10% of patients. Thus, enfuvirtide may have promoted the hepatotoxicity of tipranavir, but the effect was minor if present at all. In this instance, the enzyme elevations did not resolve until tipranavir was stopped. In the absence of serial testing of serum enzymes, bilirubin, HIV levels, CD4 counts as well as HBV DNA (with HBeAg, anti-HBe and IgM anti-HBc), the role of an exacerbation of the underlying chronic hepatitis B caused by immune reconstitution cannot be excluded.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enfuvirtide – Fuzeon®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Enfuvirtide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Enfuvirtide | 159519-65-0 | C204-H301-N51-O64

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2018

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 567-91. (Review of hepatotoxicity of antiviral medications; based upon product labeling, enfuvirtide is shown as having a ~6% incidence of "severe" drug induced liver injury).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-1664. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines. (Regularly updated guidelines on use of antiretroviral agents in adults, adolescents and children with HIV infection).
Kilby JM, Lalezari JP, Eron JJ, Carlson M, Cohen C, Arduino RC, Goodgame JC, et al. The safety, plasma pharmacokinetics, and antiviral activity of subcutaneous enfuvirtide(T-20), a peptide inhibitor of gp41-mediated virus fusion, in HIV-infected adults. AIDS Res Hum Retroviruses 2002; 18: 685-93. (Analysis of safety and efficacy of enfuvirtide in 78 patients with HIV treated for 28 days; "no significant or clinically meaningful changes or differences between dosage groups in clinical chemistry results"). 12167274
Lalezari JP, Henry K, O'Hearn M, Montaner JS, Piliero PJ, Trottier B, Walmsley S, et al.; TORO 1 Study Group. Enfuvirtide, an HIV-1 fusion inhibitor, for drug-resistant HIV infection in North and South America. N Engl J Med 2003; 348: 2175-85. (Large, registration trial of adding enfuvirtide to an "optimized" regimen in 501 patients with HIV infection and resistance to conventional antiretrovirals; updated combined safety analysis in 663 patients on enfuvirtide found 2 instances of hypersensitivity, but no mention of hepatotoxicity and rates of laboratory abnormalities were not different in enfuvirtide as control [optimal regimen] patients). 12637625
Lazzarin A, Clotet B, Cooper D, Reynes J, Arastéh K, Nelson M, Katlama C, et al.; TORO 2 Study Group. Efficacy of enfuvirtide in patients infected with drug-resistant HIV-1 in Europe and Australia. N Engl J Med 2003; 348: 2186-95. (Controlled trial of adding enfuvirtide to an "optimized" regimen in 512 patients with HIV infection and resistance to conventional antiretrovirals; updated combined safety analysis for 813 patient-years of exposure reported: "No consistent pattern was evident to suggest a definitive association of enfurvitide with any particular laboratory abnormality"). 12773645
Hardy H, Skolnik PR. Enfuvirtide, a new fusion inhibitor for therapy of human immunodeficiency virus infection. Pharmacotherapy 2004; 24: 198-211. (Review of structure, pharmacology, mechanism of action, clinical efficacy and safety of enfuvirtide: 36-amino acid synthetic peptide derived from sequence motif of HIV protein gp41, a transmembrane protein necessary for HIV fusion to CD4 cells; found to suppress HIV in culture and in humans, but must be given by injection; metabolized to amino acids which are probably reused; large registration trials [TORO-1 and 2] demonstrated efficacy and that side effects were similar to controls except for injection site reactions [97% vs nil] and eosinophilia [10% vs 2.4%], but not associated with systemic features and no mention of hepatotoxicity). 14998221
Church JA, Hughes M, Chen J, Palumbo P, Mofenson LM, Delora P, Smith E, et al.; Pediatric AIDS Clinical Trials Group P1005 Study Team. Long term tolerability and safety of enfuvirtide for human immunodeficiency virus 1-infected children. Pediatr Infect Dis J 2004; 23: 713-8. (Analysis of efficacy and safety of up to 96 weeks of enfuvirtide therapy in 14 children with HIV infection; no mention of hepatotoxicity and no instances of liver test abnormalities above 5 times ULN). 15295220
Trottier B, Walmsley S, Reynes J, Piliero P, O'Hearn M, Nelson M, Montaner J, et al. Safety of enfuvirtide in combination with an optimized background of antiretrovirals in treatment-experienced HIV-1-infected adults over 48 weeks. J Acquir Immune Defic Syndr 2005; 40: 413-21. (Follow up to 48 weeks of patients in registration trials of enfuvirtide [Lazzarin 2003 and Lalezari 2003]; no mention of hepatotoxicity or rates of ALT elevations; eosinophilia in ~12.5% per year; 6 cases of hypersensitivity, 5 recurring with rechallenge and some patients developed "elevated serum liver transaminases"). 16280695
Jülg B, Bogner JR, Goebel FD. Severe hepatotoxicity associated with the combination of enfuvirtide and tipranavir/ritonavir: case report. AIDS 2006; 20: 1563. (52 year old man with HIV-HBV co-infection developed marked increase in ALT [538 U/L] without jaundice, 2 weeks after adding tipranavir and ritonavir to a regimen of zidovudine, lamivudine and enfuvirtide, resolving in 4 weeks of stopping; possibly related to effects of enfuvirtide on drug levels, no analysis of HBV reactivation and lamivudine resistance: Case 1). 16847416
Shibuyama S, Gevorkyan A, Yoo U, Tim S, Dzhangiryan K, Scott JD. Understanding and avoiding antiretroviral adverse events. Curr Pharm Des 2006; 12: 1075-90. (Class wide adverse effects of antiretroviral agents include lactic acidosis for di-deoxynucleosides, rash and hepatitis for nonnucleoside reverse transcriptase inhibitors and lipodystrophy for protease inhibitors; fusion inhibitors such as enfuvirtide are well tolerated, but associated with frequent sometimes troubling injection site reactions and eosinophilia ). 16515487
Raffi F, Battegay M, Rusconi S, Opravil M, Blick G, Steigbigel RT, Kraft M, et al. Combined tipranavir and enfuvirtide use associated with higher plasma tipranavir concentrations but not with increased hepatotoxicity: sub-analysis from RESIST. AIDS 2007; 21: 1977-80. (Analysis of clinical trial of tipranavir/ritonavir [r] vs comparator protease inhibitors/r who received enfuvirtide; tipranavir [+31%], lopinavir [+19%] and saquinavir levels [+39%] were higher in enfuvirtide treated, but rates of ALT elevations above 5 times ULN were lower in the enfuvirtide treated [6.5% vs 13%; 1% vs 2.5%; 0.9% vs 1.6%]). 17721109
Reynes J, Arastéh K, Clotet B, Cohen C, Cooper DA, Delfraissy JF, Eron JJ, et al. TORO: ninety-six-week virologic and immunologic response and safety evaluation of enfuvirtide with an optimized background of antiretrovirals. AIDS Patient Care STDS 2007; 21: 533-43. (In follow up analysis of the registration trials of enfuvirtide extended to 96 weeks, no new safety issues emerged; no mention of hepatotoxicity or ALT elevations). 17711378
DeJesus E, Gottlieb MS, Gathe JC Jr, Greenberg ML, Guittari CJ, Zolopa AR. Safety and efficacy of enfuvirtide in combination with darunavir-ritonavir and an optimized background regimen in treatment-experienced human immunodeficiency virus-infected patients: the below the level of quantification study. Antimicrob Agents Chemother 2008; 52: 4315-9. (Among 137 patients with HIV infection receiving enfuvirtide with darunavir/ritonavir for for 24 weeks, there were 4 discontinuations and 18 serious adverse events, none were liver related; no mention of ALT elevations). 18809940
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Updated recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents: raltegravir, maraviroc and etravirine). 18677028
Wright D, Rodriguez A, Godofsky E, Walmsley S, Labriola-Tompkins E, Donatacci L, Shikhman A, et al. Efficacy and safety of 48 weeks of enfuvirtide 180 mg once-daily dosing versus 90 mg twice-daily dosing in HIV-infected patients. HIV Clin Trials 2008; 9: 73-82. (Comparison of once vs twice daily enfuvirtide added to an optimized regimen for 48 weeks in 61 patients with HIV infection; the two regimens had similar efficacy and safety; no mention of hepatotoxicity or ALT elevations). 18474492
Drugs for HIV infection. Treat Guidel Med Lett 2014; 12 (138): 7-16; (Concise review of drugs for HIV infection discusses enfuvirtide as the only fusion inhibitor approved for use in the US and mentions adverse side effects of local pain and irritation, eosinophilia, hypersensitivity reactions and increased rate of bacterial pneumonia, but does not mention ALT elevations or hepatotoxicity). 24457549
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 5 of which were attributed to antiretroviral agents, including lamivudine, zidovudine and nevirapine, but not enfuvirtide). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] were attributed to antiretroviral medications, but none specifically to enfuvirtide). 25754159
Xu F, Acosta EP, Liang L, He Y, Yang J, Kerstner-Wood C, Zheng Q, et al. Current status of the pharmacokinetics and pharmacodynamics of HIV-1 entry inhibitors and HIV therapy. Curr Drug Metab 2017; 18: 769-81. (Summary of the mechanism of action, pharmacokinetics and safety of enfuvirtide; no mention of ALT elevations or hepatotoxicity). 28738768
de Castro N, Braun J, Charreau I, Lafeuillade A, Viard JP, Allavena C, Aboulker JP, et al.; EASIER ANRS 138 study group. Incidence and risk factors for liver enzymes elevations in highly treatment-experienced patients switching from enfuvirtide to raltegravir: a sub-study of the ANRS-138 EASIER trial. AIDS Res Ther 2016; 13: 17. (Among 169 HIV infected patients on long term antiretroviral therapy who were either maintained on enfuvirtide or switched to raltegravir, serum ALT levels were more frequently elevated [above 3 times ULN] in those switched to raltegravir [7% vs 2%], but no patient developed clinically apparent liver injury and multivariate analysis suggested that tipranavir was more likely the cause of the abnormalities). 27042193

## OTHER REFERENCE LINKS

1. Recent References on Enfuvirtide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Enfuvirtide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Enfuvirtide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enfuvirtide)